# Sotagliflozin

## OVERVIEW

### Introduction

Sotagliflozin is a small molecule, dual inhibitor of the sodium-glucose cotransporters 1 and 2 that is used to reduce the risk of cardiovascular death and heart failure events in adults with heart failure or with type 2 diabetes and chronic kidney disease. Sotagliflozin has not been associated with serum aminotransferase elevations during therapy or with clinically apparent liver injury.

### Background

Sotagliflozin (soe” ta gli floe’ zin) is an orally available, small molecule, dual inhibitor of the sodium-glucose cotransporters 1 and 2 (SGLT1 and SGLT2). It exhibits a 20-fold higher potency for SGLT2 over SGLT1. Inhibition of SGLT2 blocks reabsorption of glucose and sodium in the renal proximal tubules, increasing urinary glucose excretion, while inhibition of SGLT1 delays intestinal glucose absorption. Its cardiovascular benefit is thought to arise largely from effects on sodium and volume handling, although the precise mechanism has not been established. In two large, placebo-controlled trials, sotagliflozin was found to decrease cardiovascular events or deaths in patients with diabetes and heart failure or chronic kidney disease. Sotagliflozin was approved for use in the United States in 2023, and current indications are to reduce the risk of heart failure events and cardiovascular death in adults with pre-existing heart failure or with type 2 diabetes and chronic kidney disease. It is available as 200 and 400 mg tablets under the brand name Inpefa. The recommended dose is 200 mg orally once daily, which can be increased to 400 mg once daily as tolerated. Common side effects include urinary tract infections, volume depletion (which can cause hypotension), diarrhea, hypoglycemia (particularly when combined with insulin or insulin secretagogues), dizziness, and genital mycotic [yeast] infections. Potentially serious adverse events include ketoacidosis (the risk being particularly increased in people with type 1 diabetes, for whom the drug is not indicated), serious genitourinary infections, necrotizing fasciitis of the perineum, and acute kidney injury related to volume depletion.

### Hepatotoxicity

In two large pre-registration, placebo-controlled cardiovascular outcome trials that enrolled more than 11,000 patients, serum aminotransferase elevations were no more frequent with sotagliflozin than with placebo. Rates of ALT elevations above 3 times the upper limit of normal (ULN) were similar between treatment groups (2.0% vs 2.1% in the heart failure trial; 0.9% vs 0.9% in the diabetes and kidney disease trial), and mean aminotransferase levels did not change with treatment. Potential cases of drug-induced liver injury, adjudicated by a committee blinded to the treatment group, occurred at similarly low rates in the sotagliflozin and placebo patients [1.8% vs 2.3% and 0.7% vs 0.6%]. A single sotagliflozin-treated patient met laboratory criteria for clinically apparent liver injury with jaundice, but the event occurred months after stopping the drug and was judged to be due to biliary obstruction from gallstones. The product label does not list liver injury as an adverse reaction. Since its approval, there have been no published reports of clinically apparent liver injury attributed to sotagliflozin, but clinical experience with the drug has been limited. As with other agents in the SGLT2 inhibitor class, sotagliflozin appears to be an unlikely cause of liver injury.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The reason that sotagliflozin has not been linked to liver injury is not known. Sotagliflozin is extensively metabolized in the liver, largely by glucuronidation via UGT1A9 and to a lesser extent by CYP 3A4. Systemic exposure to sotagliflozin is increased in patients with moderate and severe hepatic impairment for whom the drug is not recommended.

### Outcome and Management

Sotagliflozin has not been associated with serum aminotransferase elevations or with clinically apparent liver injury, and no specific monitoring of liver tests during therapy is recommended. Patients presenting with new hepatic abnormalities during sotagliflozin therapy should be evaluated for other causes, particularly biliary disease, before permanent discontinuation of the drug.

Drug Class: Antidiabetic Agents; Sodium-Glucose Cotransporter-2 (SGLT2) Inhibitors

Other Drugs in the Subclass, SGLT2 Inhibitors: Bexagliflozin, Canagliflozin, Dapagliflozin, Empagliflozin, Ertugliflozin

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Sotagliflozin – Inpefa®

DRUG CLASS

Antidiabetic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Sotagliflozin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Sotagliflozin | 1018899-04-1 | C21H25ClO5S | SID:483927361

## ANNOTATED BIBLIOGRAPHY

References updated: 19 September 2026

Abbreviations used: SGLT, sodium-glucose cotransporter; ULN, upper limit of normal.

Zimmerman HJ. Oral hypoglycemic agents and other diabetes therapy. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 575-9. (Expert review of hepatotoxicity of antidiabetic agents published in 1999, before the availability of the SGLT2 inhibitors).
De Marzio DH, Navarro VJ. Antidiabetic drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 519-40. (Review of hepatotoxicity of antidiabetic agents; does not discuss the SGLT2 inhibitors).
Drugs@FDA. 2023. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2023/216203Orig1s000IntegratedR.pdf (FDA website with the product label and integrated review of the efficacy and safety of sotagliflozin, submitted in support of its approval in the United States as therapy to reduce cardiovascular death and heart failure events, mentions that ALT elevations above 3 times ULN occurred in 2.0% vs 2.1% in a placebo controlled trial in 1222 patients and in 0.9% vs 0.9% in a placebo controlled trial in 10,584 patients, and there were no cases of simultaneous elevations in ALT and bilirubin that were attributed to sotagliflozin).
Bhatt DL, Szarek M, Steg PG, Cannon CP, Leiter LA, McGuire DK, Lewis JB, et al.; SOLOIST-WHF Trial Investigators. Sotagliflozin in patients with diabetes and recent worsening heart failure. N Engl J Med. 2021;384:117-128. (Among 1222 patients with type 2 diabetes recently hospitalized for worsening heart failure treated with sotagliflozin or placebo, the total of cardiovascular deaths and heart failure events was lower with sotagliflozin [51 vs 76 per 100 patient-years], while diarrhea and severe hypoglycemia were more frequent with sotagliflozin; no mention of ALT elevations or hepatotoxicity). 33200892
Bhatt DL, Szarek M, Pitt B, Cannon CP, Leiter LA, McGuire DK, Lewis JB, et al.; SCORED Investigators. Sotagliflozin in patients with diabetes and chronic kidney disease. N Engl J Med. 2021;384:129-139. (Among 10,584 patients with type 2 diabetes and chronic kidney disease treated with sotagliflozin or placebo, the total of cardiovascular deaths and heart failure events was lower with sotagliflozin [5.6 vs 7.5 per 100 patient-years], while diarrhea, genital mycotic infections, volume depletion, and diabetic ketoacidosis were more common with sotagliflozin; no mention of ALT elevations or hepatotoxicity). 33200891
Szarek M, Bhatt DL, Steg PG, Cannon CP, Leiter LA, McGuire DK, Lewis JB, et al.; SOLOIST-WHF committees and investigators. Effect of sotagliflozin on total hospitalizations in patients with type 2 diabetes and worsening heart failure: a randomized trial. Ann Intern Med. 2021;174:1065-1072. (Secondary analysis of the placebo controlled trial in 1222 patients with heart failure [Bhatt 2021] found that sotagliflozin increased days alive and out of hospital compared with placebo, primarily through a reduction in days dead; no mention of ALT elevations or hepatotoxicity). 34152828

## OTHER REFERENCE LINKS

1. Recent References on Sotagliflozin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Sotagliflozin%20+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Sotagliflozin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Sotagliflozin)